# Lurasidone

## OVERVIEW

### Introduction

Lurasidone is a second generation (atypical) antipsychotic agent that is used in the treatment of schizophrenia and bipolar depression. Lurasidone is associated with a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent acute liver injury.

### Background

Lurasidone (loo ras' i done) is a second generation antipsychotic agent which appears to act as a dopamine type 2 (D2) and serotonin (5-HT)-2A receptor antagonist in a manner similar to risperidone. Several randomized controlled trials have shown that lurasidone improves symptoms of schizophrenia and it was approved for this indication in the United States in 2010. Indications were subsequently extended to depressive episodes associated with bipolar disorder 2018. Lurasidone is available as tablets of 20, 40, 60, 80 and 120 mg generically and under the brand name Latuda. The recommended starting dose is 20 or 40 mg daily with gradual increase to a maintenance dose of 40 to 120 mg daily, the optimal dose varying by indication, concurrent medication use, renal or hepatic dysfunction and tolerance. Common side effects include somnolence, fatigue, restlessness (akathisia), anxiety, headache, dizziness, constipation, increased appetite, weight gain, orthostatic hypotension and nasopharyngitis. Rare, but potential severe adverse reactions (mentioned in most antipsychotic and antidepressant product labels) include tardive dyskinesia, major neurologic events, neuroleptic malignant syndrome, orthostatic hypotension, seizures, neutropenia, elevations in serum prolactin levels, and suicidal thoughts and behaviors. Furthermore, use of antipsychotic medications in elderly patients with dementia-related psychosis has been associated with increased mortality.

### Hepatotoxicity

Liver test abnormalities occur in 1% to 3% of patients on long term therapy with lurasidone, but similar rates have been reported with placebo therapy and with comparator agents. The ALT elevations are usually mild, transient and often resolve even without dose modification or drug discontinuation. There have been no published reports of clinically apparent liver injury with symptoms or jaundice attributed to lurasidone therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lurasidone might cause serum ALT elevations or liver injury is not known. Lurasidone is extensively metabolized by the cytochrome P450 system (CYP 3A4) to its active metabolite and is susceptible to drug-drug interactions with agents that inhibit or induce CYP 3A4.

### Outcome and Management

The serum aminotransferase elevations that occur on lurasidone therapy are usually self-limited and often do not require dose modification or discontinuation. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to lurasidone. Cross sensitivity to liver related or other hypersensitivity reactions between lurasidone and structurally related antipsychotic agents (such as iloperidone, paliperidone, risperidone and ziprasidone) have not been demonstrated, but may well occur.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lurasidone – Generic, Latuda®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lurasidone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lurasidone | 367514-87-2 | C28-H36-N4-O2-S
Risperidone | 106266-06-2 | C23-H27-F-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 10 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Larry D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 507-26. (Review of hepatotoxicity of psychiatric agents does not discuss lurasidone).
Nakamura M, Ogasa M, Guarino J, Phillips D, Severs J, Cucchiaro J, Loebel A. (2009). Lurasidone in the treatment of acute schizophrenia: a double-blind, placebo-controlled trial. J Clin Psychiatry. (Among 180 patients with an acute exacerbation of schizophrenia treated with lurasidone [80 mg daily] or placebo for 6 weeks, adverse events included nausea, vomiting, dyspepsia, constipation, anxiety, restlessness, and somnolence, and one patient stopped therapy early because of ALT and AST elevations, but few details given).
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. (2009). Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res. (Analysis of weight gain in 21 placebo-controlled trials [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, 0.6 risperidone, -0.3 ziprasidone; a 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects).
(2011). Lurasidone (Latuda) for schizophrenia. Med Lett Drugs Ther. (Brief review of efficacy and safety of lurasidone shortly after its approval in the US; common side effects are restlessness [akathisia], extrapyramidal symptoms, agitation, nausea, and somnolence: no mention of ALT elevations or liver injury).
Potkin SG, Ogasa M, Cucchiaro J, Loebel A. (2011). Double-blind comparison of the safety and efficacy of lurasidone and ziprasidone in clinically stable outpatients with schizophrenia or schizoaffective disorder. Schizophr Res. (Among 301 patients with schizophrenia treated with lurasidone [120 mg once daily] or ziprasidone [80 mg twice daily], there were no on-treatment laboratory abnormalities).
Meltzer HY, Cucchiaro J, Silva R, Ogasa M, Phillips D, Xu J, Kalali AH, et al. (2011). Lurasidone in the treatment of schizophrenia: a randomized, double-blind, placebo- and olanzapine-controlled study. Am J Psychiatry. (Among 478 patients with acute schizophrenia treated with lurasidone [40 or 120 mg daily] or olanzapine or placebo for 6 weeks, side effects attributed to lurasidone included restlessness, anxiety, agitation, nausea, and somnolence; no mention of ALT elevations or hepatotoxicity).
Citrome L, Cucchiaro J, Sarma K, Phillips D, Silva R, Tsuchiya S, Loebel A. (2012). Long-term safety and tolerability of lurasidone in schizophrenia: a 12-month, double-blind, active-controlled study. Int Clin Psychopharmacol. (Among 629 adults with schizophrenia treated with lurasidone [40 to 120 mg daily] or risperidone [2 to 6 mg daily] for 12 months, “there were no clinically significant changes from baseline to month 12 in liver enzymes”).
Stahl SM, Cucchiaro J, Simonelli D, Hsu J, Pikalov A, Loebel A. (2013). Effectiveness of lurasidone for patients with schizophrenia following 6 weeks of acute treatment with lurasidone, olanzapine, or placebo: a 6-month, open-label, extension study. J Clin Psychiatry. (Among 113 patients enrolled in an open label extension study of lurasidone, the most common adverse events were restlessness, insomnia, somnolence, nausea, headache and weight gain; no mention of ALT elevations or hepatotoxicity).
Nasrallah HA, Silva R, Phillips D, Cucchiaro J, Hsu J, Xu J, Loebel A. (2013). Lurasidone for the treatment of acutely psychotic patients with schizophrenia: a 6-week, randomized, placebo-controlled study. J Psychiatr Res. (Among 496 patients with an acute exacerbation of schizophrenia treated with lurasidone [40, 80 or 120 mg daily] or placebo for 6 weeks, common adverse events were restlessness, headaches, somnolence, nausea, sedation, and weight gain; no mention of ALT elevations or hepatotoxicity).
Loebel A, Cucchiaro J, Sarma K, Xu L, Hsu C, Kalali AH, Pikalov A, Potkin SG. (2013). Efficacy and safety of lurasidone 80 mg/day and 160 mg/day in the treatment of schizophrenia: a randomized, double-blind, placebo- and active-controlled trial. Schizophr Res. (Among 486 adults with schizophrenia treated with lurasidone [80 or 160 mg daily] or quetiapine [600 mg daily] or placebo for 6 weeks, symptom scores were improved by both agents compared to placebo, while adverse events with lurasidone included restlessness, nausea, dizziness, somnolence, and weight gain, but “no other clinically relevant differences were noted for any other laboratory values” in comparison to the placebo group).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Concise review of safety, efficacy, and role of drugs for psychiatric disorders mentions that lurasidone is a second-generation antipsychotic agent whose adverse side effects include akathisia, nausea, agitation and somnolence; no mention of ALT elevations or hepatotoxicity).
Loebel A, Cucchiaro J, Silva R, Kroger H, Hsu J, Sarma K, Sachs G. (2014). Lurasidone monotherapy in the treatment of bipolar I depression: a randomized, double-blind, placebo-controlled study. Am J Psychiatry. (Among 505 patients with major depression and bipolar illness treated with lurasidone [20-60 mg or 80-120 mg daily] or placebo for 6 weeks, symptoms of depression improved with lurasidone therapy, while common side effects were nausea, headache, restlessness, and somnolence and “there were no notable differences in laboratory measures” between treatment groups).
Musil R, Obermeier M, Russ P, Hamerle M. (2015). Weight gain and antipsychotics: a drug safety review. Expert Opin Drug Saf. (Extensive systematic review of the literature on the problem of weight gain during therapy with antipsychotic agents mentions that weight gain of 7% or more occurs in 1-14% of patients on lurasidone and averages -1 to +1.3 kg, rates being lower than with most other atypical antipsychotics).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 patients with drug induced liver injury seen over a ten-year period at 8 US medical centers, one case was attributed to olanzapine, but none to lurasidone or other antipsychotic medications).
Suppes T, Silva R, Cucchiaro J, Mao Y, Targum S, Streicher C, Pikalov A, et al. (2016). Lurasidone for the treatment of major depressive disorder with mixed features: A randomized, double-blind, placebo-controlled study. Am J Psychiatry. (Among 209 adults with major depressive disorder with mixed features treated with lurasidone [20-60 mg daily] or placebo for 6 weeks, symptoms [including mania] improved more with lurasidone, while common adverse events were nausea [6.4%], somnolence [5.5%] and akathisia [3.7%]; no mention of ALT elevations or hepatotoxicity).
Potkin SG, Kimura T, Guarino J. (2015). A 6-week, double-blind, placebo- and haloperidol-controlled, phase II study of lurasidone in patients with acute schizophrenia. Ther Adv Psychopharmacol. (Among 138 patients with schizophrenia treated with lurasidone [20, 40 or 80 mg daily] or haloperidol and placebo for 6 weeks, there were no differences in psychosis associated symptoms among the different groups and side effects of lurasidone included sedation, dyspnea, nausea and akathisia; no mention of ALT elevations or hepatotoxicity).
Correll CU, Cucchiaro J, Silva R, Hsu J, Pikalov A, Loebel A. (2016). Long-term safety and effectiveness of lurasidone in schizophrenia: a 22-month, open-label extension study. CNS Spectr. (Among 251 patients with schizophrenia rolled over into an open-label trial of lurasidone [40 to 120 mg daily] for 6-24 months, there "was no evidence for hepatic toxicity" but were minor changes in ALT and AST levels and 4 subjects [1.7%] "had a markedly abnormal ALT" although none required discontinuation and all except one resolved).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
DelBello MP, Goldman R, Phillips D, Deng L, Cucchiaro J, Loebel A. (2017). Efficacy and Safety of Lurasidone in children and adolescents with bipolar I depression: a double-blind, placebo-controlled study. J Am Acad Child Adolesc Psychiatry. (Among 347 children and adolescents with bipolar depression ages 10 to 17 treated with lurasidone or placebo for 6 weeks, depression symptom scores improved more with lurasidone, and adverse events included nausea [16% vs 6%], somnolence [11% vs 6%], weight gain [7% vs 2%] and insomnia [5% vs 2%]; no mention of ALT elevations or hepatotoxicity).
Goldman R, Loebel A, Cucchiaro J, Deng L, Findling RL. (2017). Efficacy and Safety of lurasidone in adolescents with schizophrenia: a 6-week, randomized placebo-controlled study. J Child Adolesc Psychopharmacol. (Among 326 adolescents with schizophrenia treated with lurasidone [40 or 80 mg daily] or placebo for 6 weeks, improvements in symptom scores were greater with lurasidone as were side effects of nausea, akathisia, somnolence, and extrapyramidal events; no mention of ALT elevations or hepatotoxicity).
Pikalov A, Tsai J, Mao Y, Silva R, Cucchiaro J, Loebel A. (2017). Long-term use of lurasidone in patients with bipolar disorder: safety and effectiveness over 2 years of treatment. Int J Bipolar Disord. (Among 122 patients with bipolar disorder enrolled in short term, controlled trials who were rolled over into an 18-month extension study of lurasidone [mean dose 62 mg daily], adverse events were reported in 43% of patients, including 3% with liver test abnormalities and 1 subject who discontinued therapy early for that reason).
Higuchi T, Iyo M, Kwon JS, Chou YH, Chen HK, Chen JY, Chen TT, et al. (2019). Randomized, double-blind, placebo, and risperidone-controlled study of lurasidone in the treatment of schizophrenia: results of an inconclusive 6-week trial. Asia Pac Psychiatry. (Among 460 hospitalized Asian patients with schizophrenia treated with lurasidone [40 or 80 mg], risperidone [4 mg] or placebo once daily for 6 weeks, improvement in scores for psychosis symptoms was similar in all 4 groups while adverse event rates were greater with active treatment; no mention of ALT elevations or hepatotoxicity).
Kato T, Ishigooka J, Miyajima M, Watabe K, Fujimori T, Masuda T, Higuchi T, et al. (2020). Double-blind, placebo-controlled study of lurasidone monotherapy for the treatment of bipolar I depression. Psychiatry Clin Neurosci. (Among 525 Japanese patients with bipolar 1 depression treated with 2 doses of lurasidone or placebo for 6 weeks, improvements in depression symptoms scores were slightly greater with lurasidone [-13.6 and -12.6 vs -10.6] as were adverse events including akathisia [13% and 24% vs 6%] and nausea [6.5% and 11.8% vs 6%], and there was “no evidence of toxicity as measured by laboratory…parameters’).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients; low rates were found for ziprasidone [no cases among 3568 patients treated] and aripiprazole [6 cases of 15,988 patients treated: 0.01%]; lurasidone not listed).
DelBello MP, Tocco M, Pikalov A, Deng L, Goldman R. (2021). Tolerability, safety, and effectiveness of two years of treatment with lurasidone in children and adolescents with bipolar depression. J Child Adolesc Psychopharmacol. (Among 306 adolescents with bipolar depression treated with lurasidone for up to 2 years in open label studies, improvements in symptoms with lurasidone were sustained and adverse events included headache [24%], nausea [16%], and somnolence [10%], and led to drug discontinuation in 10%; no mention of ALT elevations or hepatotoxicity).
Iyo M, Ishigooka J, Nakamura M, Sakaguchi R, Okamoto K, Mao Y, Tsai J, et al. (2021). Efficacy and safety of lurasidone in acutely psychotic patients with schizophrenia: A 6-week, randomized, double-blind, placebo-controlled study. Psychiatry Clin Neurosci. (Among 483 adults with schizophrenia treated with lurasidone or placebo for 6 weeks, improvements in symptoms were greater with lurasidone as were adverse events of akathisia, dizziness, somnolence and abdominal pain, but there were “no clinically meaningful” differences in mean change from baseline in blood chemistry results between the two groups).
Ishigooka J, Kato T, Miyajima M, Watabe K, Masuda T, Hagi K, Higuchi T. (2021). Lurasidone in the long-term treatment of bipolar I depression: a 28-week open label extension study. J Affect Disord. (Among 413 adults with bipolar depression who participated in short term controlled trials of lurasidone and were then enrolled in a 28 week, open label, flexible dose [20-120 mg daily] extension study, improvement in symptoms continued and adverse events were mild-to-moderate with no hepatic serious adverse events, and there “was no evidence of toxicity as measured by clinical laboratory” test results).
Miura I, Watabe K, Sakaguchi R, Okamoto K, Maruyama H. (2022). Effectiveness of lurasidone 80 mg in patients with schizophrenia: results of an open-label, 12-week extension study. Neuropsychiatr Dis Treat. (Among 289 adults with an acute exacerbation of schizophrenia participating in a 6 week controlled trial of lurasidone vs placebo who were then treated for 12 weeks with either 40 or 80 mg of lurasidone, symptom improvement was greater with the higher dose, but so were adverse event rates [55% vs 46%], although most were mild-to-moderate and transient; no mention of ALT levels or hepatotoxicity).
Correll CU, Tocco M, Hsu J, Goldman R, Pikalov A. (2022). Short-term efficacy and safety of lurasidone versus placebo in antipsychotic-naïve vs. previously treated adolescents with an acute exacerbation of schizophrenia. Eur Psychiatry. (Among 326 adolescents with schizophrenia treated with lurasidone or placebo for 6 weeks, improvements in symptoms were greater with lurasidone particularly among treatment-naïve subjects, while side effects were also greater including specific symptoms of akathisia and nausea; no mention of ALT elevations or hepatotoxicity).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine but none for lurasidone, risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury, quetiapine and risperidone as having moderate risk, haloperidol as having low risk, and paliperidone, aripiprazole, lurasidone, and loxapine as having low risk).

## OTHER REFERENCE LINKS

1 Recent References on Lurasidone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lurasidone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lurasidone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lurasidone)